# Nebivolol

## OVERVIEW

### Introduction

Nebivolol is a beta-blocker and antihypertensive medication that has additional vasodilatory activity mediated by nitric oxide release. Nebivolol has yet to be linked to instances of clinically apparent liver injury.

### Background

Nebivolol (ne biv' oh lol) is an antihypertensive agent that has both beta-adrenergic receptor blocking activity and separate direct vasodilatory actions. The beta blockade is cardioselective, acting largely on beta-1 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the atrioventricular (AV) conduction and suppressing automaticity. Nebivolol also has vasodilatory activity that is not explained by typical beta blockade and appears to be mediated by release of nitric oxide from endothelial cells. Nebivolol was approved for use in the United States in 2007 and it is currently indicated for the management of hypertension either as monotherapy or in combination with other antihypertensive agents. Nebivolol is available in tablets of 2.5, 5, 10 and 20 mg under the trade name Bystolic. The typical initial oral dose in adults is 5 mg once daily, with subsequent dose modification based upon clinical response and tolerance; the total daily maintenance dose ranges from 5 to 40 mg. Common side effects of nebivolol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and, less commonly, severe hypotension, heart failure and bronchospasm. Sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on beta-blockers and are usually transient and asymptomatic, resolving even with continuation of therapy. There is no information on the rates of ALT elevations during nebivolol therapy. Despite its use in several large clinical trials, nebivolol has not been linked to cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Nebivolol undergoes extensive metabolism by the liver, is a substrate of CYP 2D6 and its excretion is largely biliary. The liver injury linked to other beta-blockers is likely to be idiosyncratic.

References to the safety and potential hepatotoxicity of nebivolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nebivolol – Bystolic®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nebivolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nebivolol | 42200-33-9 | C17-H27-N-O4 | Nebivolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Nebivolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nebivolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nebivolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nebivolol)